# Colestipol

## OVERVIEW

### Introduction

Colestipol is a nonabsorbed bile acid sequestrant that is used a therapy of hyperlipidemia and for the pruritus of chronic liver disease and biliary obstruction. Colestipol has not been associated with clinically apparent liver injury.

### Background

Colestipol (koe les' ti pol) is a large, highly positively charged anion exchange resin that binds to negatively charged anions such as bile acids (as well as other organic compounds and some medications). The binding of bile acids to colestipol creates an insoluble compound that cannot be reabsorbed and is thus excreted in the feces. Bile acids ordinarily undergo extensive (>95%) enterohepatic recirculation, being secreted in bile, acting as fat solubilizing compounds in the upper intestine, and then being reabsorbed in the distal small bowel. Chronic loss of bile acids from colestipol use results in a contraction of the total bile acid pool. The liver compensates for this decrease by increasing bile acid synthesis, which directly competes with cholesterol synthesis resulting in a decrease in serum levels of cholesterol. Some of the decrease in serum cholesterol may also result from inhibition of fat absorption by the binding of bile acids to colestipol. Colestipol was approved for use in the United States in 1977 and is one of the oldest and safest cholesterol lowering agents, but it is currently used largely as an adjunctive therapy when statins or other lipid lowering agents result in an inadequate decrease in cholesterol levels. Colestipol is used off-label to reduce the pruritus of chronic liver disease probably as a result of binding the “pruritogen” in the intestine (which is either a bile acid or an organic anion like a bile acid that undergoes enterohepatic circulation). Colestipol is available in multiple generic forms and under the brand name of Colestid as a tablet of 2 grams or as powdered granules. The usual dose of colestipol tablets is 2 grams daily increasing to a maximum of 16 grams; whereas, that for the granules is 5 grams daily increasing to a maximum of 30 grams, based upon tolerance and effect. Colestipol is best given before meals and at bedtime. Other drugs should be given 1 hour before or 4 to 6 hours after colestipol. Colestipol granules can be unpalatable and difficult to swallow. Other side effects include abdominal discomfort, indigestion, nausea, flatuence and constipation.

### Hepatotoxicity

There is little evidence that colestipol causes liver injury. Mild elevations in serum aminotransferase and alkaline phosphatase levels have been reported in small numbers of patients on bile acid resins, although the elevations have been mild, transient and without accompanying symptoms. In addition, a case report of more marked aminotransferase elevations (>10 times ULN) with rapid recovery on stopping colestipol has been published, but the mechanism by which it might cause hepatotoxicity is very unclear. Colestipol is used in patients with liver disease to treat pruritus, and has little or no effect on serum enzyme or bilirubin levels.

Likelihood score: E (unlikely cause of clinically apparent liver injury with jaundice).

### Mechanism of Injury

The lack of hepatic injury by colestipol is probably due to the fact that it is not absorbed, and the contraction of the bile acid pool caused by its use does not harm the liver. Because colestipol can interfere with the absorption of other medications or vitamins, it may indirectly worsen liver disease by lowering effective levels of medications. These effects are particularly important for vitamins A, D, E, K, hormones such as estrogens, corticosteroids, and thyroid hormone, and medications such as thiazide diuretics, acetaminophen and digoxin.

References on the safety and hepatotoxicity of colestipol are given with those for colesevelam and cholestyramine in the Overview section on Bile Acid Resins/Sequestrants.

Drug Class: Antilipemic Agents, Bile Acid Resins/Sequestrants

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Colestipol – Generic, Colestid®

DRUG CLASS

Antilipemic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=colestipol)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Colestipol | 50925-79-6 | Unspecified | Image of Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Colestipol: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=colestipol+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Colestipol: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=colestipol)